# Zepatier

## OVERVIEW

### Introduction

Zepatier is an oral, fixed combination of two antiviral agents, elbasvir and grazoprevir, that is used to treat chronic hepatitis C, genotypes 1 and 4. This antiviral combination has been associated with low rate of transient serum enzyme elevations during therapy, but has not been implicated in cases of clinically apparent idiosyncratic liver injury with jaundice. However, like all effective direct acting antiviral agents for hepatitis C, Zepatier is considered capable of causing reactivation of hepatitis B in susceptible patients and transient hepatic decompensation in patients with cirrhosis.

### Background

Zepatier is the commercial name for a combination of elbasvir and grazoprevir, two antiviral agents used to treat chronic hepatitis C associated with HCV genotypes 1 and 4. The hepatitis C virus (HCV) encodes several nonstructural (NS) polypeptides that are essential for its replication, NS3/4 that has protease and helicase activities, NS5A that is a membrane bound polypeptide of uncertain purpose, and NS5B an HCV specific, RNA-dependent, RNA polymerase. These polypeptides are effective targets for antiviral therapy of hepatitis C. Zepatier is a fixed dose combination of grazoprevir (graz oh’ pre vir) which is a potent HCV NS3/4 protease inhibitor and elbasvir (elb’ as vir) an NS5A inhibitor. In cell culture and in humans infected with HCV, each of these agents has potent activity against HCV, but antiviral resistance arises rapidly with continued exposure. The combination of the two direct acting agents with different molecular targets allows for a sustained viral suppression while avoiding antiviral resistance. The combination of these two agents with and without the ribavirin (an antiviral nucleoside analogue with activity against HCV) was shown to be very effective in suppressing HCV replication in patients infected with HCV genotypes 1 and 4, and to result in sustained virological responses and eradication of HCV in more than 95% of patients when given for 12 or 16 weeks. Zepatier was approved for use in the United States in 2016, the third all-oral antiviral combination to receive approval for chronic hepatitis C. It is available as tablets with the fixed dose combination of 100 mg of grazoprevir and 50 mg of elbasvir. The recommended dose in adults is 1 tablet daily for 12 weeks. The addition of ribavirin for 12 weeks and prolongation of therapy to 16 weeks is recommended for some groups of HCV infected patients, such as those with previous non-response to antiviral therapy and those with genotype 1a and preexisting resistance associated viral variants. Current indications are limited to patients with HCV genotypes 1 and 4. Side effects are uncommon, but are generally mild and can include fatigue, headache and nausea.

### Hepatotoxicity

In large randomized controlled trials, serum aminotransferase elevations more than 5 times the upper limit of normal (ULN) occurred in 1% of Zepatier treated patients, but were infrequent in placebo recipients. The elevations were generally asymptomatic and short-lived, often arising after the first 4 weeks of therapy and resolving with or without dose modification and only rarely requiring early discontinuation. In some instances, ALT levels rose above 10 times the upper limit of normal, but these elevations were not accompanied by symptoms or jaundice and were invariably self-limited. In the many preregistration trials, Zepatier was not associated with instances of clinically apparent liver injury.

However, two forms of liver injury have been associated with direct-acting antiviral agents used to treat chronic hepatitis C, and these reactions appear to occur with all regimens. The first is acute decompensation of HCV-related cirrhosis. The liver injury usually arises within 2 to 6 weeks of starting antiviral therapy, but can occur later and even after discontinuation. The injury is marked by worsening jaundice and appearance of signs of hepatic failure such as ascites or hepatic encephalopathy, often with little or no change in serum aminotransferase levels. Lactic acidosis may be present early. The course is variable but calls for prompt discontinuation of treatment despite successful suppression of HCV RNA levels. Some instances have led to death or need for emergency liver transplantation. For this reason, patients with cirrhosis undergoing antiviral therapy with potent direct acting agents, such as Zepatier, should be monitored carefully, particularly during the first few weeks of treatment. This syndrome has not been clearly linked to therapy with grazoprevir and elbasvir, but this regimen has not been evaluated in patients with advanced cirrhosis due to hepatitis C.

A second, liver complication of therapy of chronic hepatitis C is reactivation of hepatitis B. This occurs most frequently in patients who have HBsAg in serum but rare instances have arisen in subjects with anti-HBc without HBsAg. The cause of the reactivation of hepatitis B during antiviral therapy of hepatitis C is unknown, but may relate to the inhibition of HBV replication during HCV replication. For this reason, patients with hepatitis C who are to receive antiviral therapy should be screened for HBsAg and anti-HBc. Those with HBsAg are best managed by concurrent treatment with an antiviral agent active against HBV, such as entecavir or tenofovir. Subjects with anti-HBc without HBsAg rarely experience reactivation and can be managed by careful monitoring for HBV DNA levels during treatment and institution of therapy for HBV if levels appear de novo or rise significantly. Reactivation of hepatitis B has been described with many regimens, although not specifically with grazoprevir and elbasvir.

Likelihood score: C (probable, rare cause of liver injury, including decompensation of chronic hepatitis C and reactivation of hepatitis B).

### Mechanism of Injury

The mechanism by which elbasvir and grazoprevir might cause liver injury is not known. Both are metabolized in the liver largely via the cytochrome P450 system, predominantly CYP 1A2, and liver injury may be due to production of a toxic or immunogenic metabolite. Zepatier is also susceptible to drug-drug interactions with strong inducers or inhibitors of CYP 3A4. Reactivation of hepatitis B during therapy of chronic hepatitis C is probably due to eradication of a competing virus for replicative space.

### Outcome and Management

While chronic therapy with grazoprevir and elbasvir can be associated with mild-to-moderate serum aminotransferase elevations, it has not been convincingly linked to cases of clinically apparent liver injury. Nevertheless, monitoring of serum aminotransferase levels monthly during the 12 weeks of therapy is recommended. Patients who develop aminotransferase elevations on therapy should be monitored more carefully, and Zepatier should be permanently discontinued if jaundice or symptoms of liver injury arise or if serum ALT or AST levels are persistently above 5 times the ULN. Patients with cirrhosis should be monitored for signs and symptoms of hepatic decompensation and therapy stopped promptly if these arise. All patients receiving antiviral therapy for hepatitis C should be screened for HBsAg and anti-HBc and either monitored carefully for evidence of reactivation or given prophylaxis with agents active against hepatitis B during therapy and for several weeks thereafter.

Drug Class: Antiviral Agents, Hepatitis C Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Elbasvir, Grazoprevir – Zepatier®

DRUG CLASS

Hepatitis C Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=zepatier%3Cbr%3EGrazoprevir,%20Elbasvir)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULAS AND STRUCTURES

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Elbasvir | 1370468-36-2 | C49-H55-N9-O7
Grazoprevir | 1350462-55-3 | C38-H50-N6-O9-S.H2-O

## ANNOTATED BIBLIOGRAPHY: Zepatier, Elbasvir, Grazoprevir

References updated: 07 February 2022

Forns X, Gordon SC, Zuckerman E, Lawitz E, Calleja JL, Hofer H, Gilbert C, et al. (2015). Grazoprevir and elbasvir plus ribavirin for chronic HCV genotype-1 infection after failure of combination therapy containing a direct-acting antiviral agent. J Hepatol. (Among 79 adults with previously treated chronic hepatitis C, genotype 1, who received grazoprevir, elbasvir and ribavirin for 12 weeks, the overall response rate was 96%, 5 had a serious adverse event, but none were hepatic and no patient had ALT elevations above baseline).
Lawitz E, Gane E, Pearlman B, Tam E, Ghesquiere W, Guyader D, Alric L, et al. (2015). Efficacy and safety of 12 weeks versus 18 weeks of treatment with grazoprevir (MK-5172) and elbasvir (MK-8742) with or without ribavirin for hepatitis C virus genotype 1 infection in previously untreated patients with cirrhosis and patients with previous null response with or without cirrhosis (C-WORTHY): a randomised, open-label phase 2 trial. Lancet. (Among 253 patients with chronic hepatitis C genotype 1 treated with grazoprevir and elbasvir with or without ribavirin for 12 or 18 weeks, response rates averaged 95% [90-100%] and were independent of ribavirin or duration; serious adverse events occurred in 3% and late elevations in ALT in 6 [2%], which were self-limited in all and above 5 times ULN in only 1 patient).
Sulkowski M, Hezode C, Gerstoft J, Vierling JM, Mallolas J, Pol S, Kugelmas M, et al. (2015). Efficacy and safety of 8 weeks versus 12 weeks of treatment with grazoprevir (MK-5172) and elbasvir (MK-8742) with or without ribavirin in patients with hepatitis C virus genotype 1 mono-infection and HIV/hepatitis C virus co-infection (C-WORTHY): a randomised, open-label phase 2 trial. Lancet. (Among 218 patients with chronic hepatitis C, genotype 1 with or without HIV infection who were treated with grazoprevir and elbasvir with or without ribavirin in 5 different treatment groups, the overall response rate was 80% with 8 weeks and 87-96% with 12 weeks of treatment; late elevations in ALT or AST occurred in 3 patients, but all were less than 5 times ULN and did not result in dose modification or early discontinuations).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 were attributed to antiviral agents, but none for the oral direct acting agents used to treat chronic hepatitis C).
Zeuzem S, Ghalib R, Reddy KR, Pockros PJ, Ben Ari Z, Zhao Y, Brown DD, et al. (2015). Grazoprevir-elbasvir combination therapy for treatment-naive cirrhotic and noncirrhotic patients with chronic hepatitis C virus genotype 1, 4, or 6 infection: a randomized trial. Ann Intern Med. (Among 421 patients with chronic hepatitis C, genotypes 1, 4 and 6, treated with grazoprevir and elbasvir or placebo for 12 weeks, the overall response rate was 95% and serious adverse events occurred in 3% of both groups; late ALT or AST elevations above twice normal occurred in 7 patients and were above 5 times ULN in 4 [1.3%], leading to early discontinuation in 2 patients but not associated with elevations in bilirubin or symptoms).
Buti M, Gordon SC, Zuckerman E, Lawitz E, Calleja JL, Hofer H, Gilbert C, et al. (2016). Grazoprevir, elbasvir, and ribavirin for chronic hepatitis C virus genotype 1 infection after failure of pegylated interferon and ribavirin with an earlier-generation protease inhibitor: final 24-week results from C-SALVAGE. Clin Infect Dis. (Among 79 patients with chronic hepatitis C, genotype 1, who had failed previous therapy with peginterferon, ribavirin and a protease inhibitor and who were treated with a 12 week course of grazoprevir, elbasvir and ribavirin, the overall response rate was 96%; no mention of adverse events [see Forns 2015]).
Rockstroh JK, Nelson M, Katlama C, Lalezari J, Mallolas J, Bloch M, Matthews GV, et al. (2015). Efficacy and safety of grazoprevir (MK-5172) and elbasvir (MK-8742) in patients with hepatitis C virus and HIV co-infection (C-EDGE CO-INFECTION): a non-randomised, open-label trial. Lancet HIV. (Among 218 patients with chronic hepatitis C, genotypes 1 and 4, and HIV coinfection treated with grazoprevir and elbasvir for 12 weeks, the overall response rate was 96%, 2 patients had unexplained elevations in ALT and AST above 5 times ULN, but both resolved without dose modification and without symptoms or jaundice).
Roth D, Nelson DR, Bruchfeld A, Liapakis A, Silva M, Monsour H, Martin P, et al. (2015). Grazoprevir plus elbasvir in treatment-naive and treatment-experienced patients with hepatitis C virus genotype 1 infection and stage 4-5 chronic kidney disease (the C-SURFER study): a combination phase 3 study. Lancet. (Among 224 patients with chronic hepatitis C, genotype 1, and renal insufficiency who were treated with grazoprevir and elbasvir or placebo for 12 weeks, the response rate to active therapy was 94% and adverse events were similar if not less among antiviral vs placebo treated patients, serious adverse events occurring in 14% vs 17%, deaths in 0.8% vs 2.7% and ALT elevations in 3% vs 38%).
European Association for Study of Liver. (2015). EASL Recommendations on Treatment of Hepatitis C 2015. J Hepatol. (Guidelines for the antiviral therapy of chronic hepatitis C from the European liver disease research and academic society).
AASLD/IDSA HCV Guidance Panel. (2015). Hepatitis C guidance: AASLD-IDSA recommendations for testing, managing, and treating adults infected with hepatitis C virus. Hepatology. (Guidelines for the antiviral therapy of chronic hepatitis C from the US liver and infectious diseases research and academic societies).
(2016). Elbasvir/grazoprevir (Zepatier) for hepatitis C. Med Lett Drugs Ther. (Concise review of the mechanism of action, clinical efficacy, side effects and costs of the fixed combination of elbasvir and grazoprevir known as Zepatier, shortly after its approval for use in the United States, mentions minor side effects of fatigue, headache and nausea and that ALT elevations occurred in 1% of treated patients and that the agent is contraindicated in patients with cirrhosis).
Dore GJ, Altice F, Litwin AH, Dalgard O, Gane EJ, Shibolet O, Luetkemeyer A, et al. (2016). C-EDGE CO-STAR Study Group. Elbasvir-grazoprevir to treat hepatitis C virus infection in persons receiving opioid agonist therapy: a randomized trial. Ann Intern Med. (Among 301 adults with chronic hepatitis C [genotype 1, 4 or 6] who were receiving opioid agonist therapy and were treated with elbasvir and grazoprevir vs placebo for 12 weeks, the SVR rates were 91% vs 0%, and ALT elevations above 3 times baseline occurred in placebo recipients only [2%]).
Sperl J, Horvath G, Halota W, Ruiz-Tapiador JA, Streinu-Cercel A, Jancoriene L, Werling K, et al. (2016). Efficacy and safety of elbasvir/grazoprevir and sofosbuvir/pegylated interferon/ribavirin: A phase III randomized controlled trial. J Hepatol. (Concise summary of the efficacy, side effects, drug interactions and costs of grazoprevir and elbasvir shortly after the approval of Zepatier in the US mentions that ALT elevations occur in 1% of patients but are generally transient and asymptomatic, and that Zepatier is considered contraindicated in patients with advanced cirrhosis).
Brown A, Hézode C, Zuckerman E, Foster GR, Zekry A, Roberts SK, Lahser F, et al. (2018). C-SCAPE Study Investigators. Efficacy and safety of 12 weeks of elbasvir ± grazoprevir ± ribavirin in participants with hepatitis C virus genotype 2, 4, 5 or 6 infection: The C-SCAPE study. J Viral Hepat. (Among 98 adults with chronic hepatitis C with genotypes 2, 4, 5 and 6 treated with grazoprevir and elbasvir, two had late rises in ALT, but details were not provided).
Gane E, Nahass R, Luketic V, Asante-Appiah E, Hwang P, Robertson M, Wahl J, et al. (2017). Efficacy of 12 or 18 weeks of elbasvir plus grazoprevir with ribavirin in treatment-naïve, noncirrhotic HCV genotype 3-infected patients. J Viral Hepat. (Among 41 patients with chronic hepatitis C, genotype 3, without cirrhosis who were treated with elbasvir, grazoprevir and ribavirin, SVR rates were 45% [12 weeks] and 57% [18 weeks of therapy], and there were no late rises in ALT or AST levels).
Boyd SD, Tracy L, Komatsu TE, Harrington PR, Viswanathan P, Murray J, Sherwat A. US. (2017). FDA perspective on elbasvir/grazoprevir treatment for patients with chronic hepatitis C virus genotype 1 or 4 infection. Clin Drug Investig. (Summary of data on efficacy of elbasvir and grazoprevir that supported their FDA approval as therapy of hepatitis C, mentions SVR rates of 92-94% for genotype 1a, 96-99% for genotype 1b, and 96-100% for genotype 4; no discussion of adverse events, ALT elevations or hepatic decompensation during therapy).
Zeuzem S, Serfaty L, Vierling J, Cheng W, George J, Sperl J, Strasser S, et al. (2018). The safety and efficacy of elbasvir and grazoprevir in participants with hepatitis C virus genotype 1b infection. J Gastroenterol. (Among 1070 adults with chronic hepatitis C, genotype 1b, treated with elbasvir and grazoprevir for 12 weeks in 11 prelicensure studies, the overall SVR rate was 97%, and 12 patients [1%] had a late rise in ALT levels to above 5 times ULN, none of whom developed jaundice, but 2 had therapy discontinued early with peak ALT levels of 472 and 703 U/L).
Nassar AH, Abdul-Jawad BM, Barnes DS. (2018). Hepatic failure due to cholestatic hepatitis C in an immunosuppressed patient treated With elbasvir and grazoprevir. ACG Case Rep J. (73 year old man with chronic inflammatory demyelinating polyneuropathy on prednisone and intravenous immunoglobulin therapy developed acute hepatitis C with a fulminant cholestatic course was started on elbasvir and grazoprevir, but continued to worsen and died 12 days later).
Matsumoto K, Kikuchi K, Kajiyama Y, Takano Y, Mabuchi M, Doi S, Sato K, et al. (2018). Development of autoimmune hepatitis during direct-acting antiviral therapy for chronic hepatitis C virus infection. Intern Med. (81 year old Japanese woman with chronic hepatitis C, genotype 1, with normal liver enzymes was treated with elbasvir and grazoprevir and developed an acute hepatitis 2 months later despite having cleared HCV RNA [bilirubin 0.9 mg/dL, ALT 739 U/L Alk P 378 U/L, ANA positive, IgG 3182 mg/dL] with a biopsy suggestive of autoimmune hepatitis and a subsequent response to prednisone therapy).
Hernández-Conde M, Fernández I, Perelló C, Gallego A, Bonacci M, Pascasio JM, Romero-Gómez M, et al. (2019). Effectiveness and safety of elbasvir/grazoprevir therapy in patients with chronic HCV infection: results from the Spanish HEPA-C real-world cohort. J Viral Hepat. (Among 588 patients with chronic hepatitis C treated with elbasvir and grazoprevir and enrolled in a national Spanish registry, the SVR rate was 97% and adverse events were reported in 80 patients [14%], leading to discontinuation in three [headache, rash, and psychiatric event], and one patient with pre-existing cirrhosis developed hepatic decompensation that was considered incidental).
Jacobson IM, Poordad F, Firpi-Morell R, Everson GT, Verna EC, Bhanja S, Hwang P, et al. (2019). Elbasvir/grazoprevir in people with hepatitis C genotype 1 infection and Child-Pugh class B cirrhosis: The C-SALT Study. Clin Transl Gastroenterol. (Among 30 patients with chronic hepatitis C and Child’s class B cirrhosis treated with elbasvir and grazoprevir for 12 weeks, the SVR rate was 90% and adverse events were common [85%,] but none were considered severe; one patient had a mild transient ALT elevation [<2.5 times ULN] and one patient died of spontaneous bacterial peritonitis and decompensation during follow up of therapy who had no ALT elevations during treatment and had an SVR).
Quaranta MG, Rosato S, Ferrigno L, Amoruso DC, Monti M, Di Stefano P, Filomia R, et al., PITER collaborating group. (2020). Real-life use of elbasvir/grazoprevir in adults and elderly patients: a prospective evaluation of comedications used in the PITER cohort. Antivir Ther. (Among 356 Italian adults with chronic hepatitis C [15% with cirrhosis] treated with elbasvir and grazoprevir with or without ribavirin for 12 weeks, the SVR rate was 95% and there were no serious adverse events, minor elevations in ALT levels at the end of therapy occurred in 2 subjects [<1%]).
Fianchi F, Ponziani FR, Pompili M. (2020). Primary biliary cholangitis development after hepatitis C virus eradication with direct acting antivirals: a case report and review of the literature. Eur Rev Med Pharmacol Sci. (84 year old man with chronic hepatitis C but normal liver tests was treated with elbasvir and grazoprevir with rapid and sustained loss of HCV RNA, but rise of liver tests by the end of therapy [bilirubin 0.6 mg/dL, ALT 1.5 times ULN, Alk P 252 U/L rising thereafter to 583 U/L], with positive AMA [1:40] and prompt improvement with ursodiol).
Hsieh YC, Lin CL, Hung CH, Chen CH, Tung SY, Lin CY, Hu TH, et al. (2020). Real-world experience of elbasvir/grazoprevir in Taiwan: This study was focused on liver and renal adverse effects. J Viral Hepat. (Among 350 adults with chronic hepatitis C [94% with advanced fibrosis or cirrhosis] treated with elbasvir and grazoprevir at 4 Taiwanese centers, the SVR rate was 95% and severe adverse events arose in 7 patients [2%], including autoimmune hepatitis in one 6 year old woman with rising ALT levels despite HCV RNA negativity and compatible biopsy responding promptly to prednisone and azathioprine; ALT elevations occurred in 28%, 23% were mild, with only 5.2% above 3 times ULN; one patient died of hepatic failure after the end of treatment, and 2 developed a flare of preexisting hepatitis B).
Puenpatom A, Cao Y, Yu X, Kanwal F, El-Serag HB, Kramer JR. (2020). Effectiveness of elbasvir/grazoprevir in US veterans with chronic hepatitis C virus genotype 1b infection. Infect Dis Ther. (Among 3371 adults with chronic hepatitis C [25% with cirrhosis] and genotype 1b treated with elbasvir and grazoprevir for 8, 12 or 16 weeks with or without ribavirin from a national VA database, the SVR rate was 97.5%; no mention of adverse events).
Liu YC, Jeng WJ, Cheng YT, Hsieh YC, Teng W, Chen YC, Lin CY, et al. (2020). Incidence and predictors for abnormal liver function during direct-acting antiviral agents in chronic hepatitis C patients. Medicine (Baltimore). (Among 1563 patients with chronic hepatitis C treated with direct acting antiviral agents between 2015-2019 at a single Chinese medical center, the SVR rate was 98% and on treatment ALT elevations arose in 11%, with higher rates in those with cirrhosis, with elevated levels pretreatment, and in those receiving asunaprevir with daclatasvir [40%], compared to Zepatier [12.3%], sofosbuvir-based regimens [11.6%] and Mavyret [5.4%]; on-treatment ALT elevations were not associated with a lower SVR rate).
Nangia G, Vierling JM, Kwo P, Brown DD, Klopfer SO, Robertson MN, Haber BA, et al. (2020). Safety and tolerability of elbasvir/grazoprevir in chronic hepatitis C virus therapy: Integrated analysis from clinical trials. J Viral Hepat. (Among 1743 adults with chronic hepatitis C treated with elbasvir and grazoprevir for 12 weeks in 12 clinical trials, the overall adverse event rate was 61%, considered drug related in 28%, serious in 2.1%, and resulting in early discontinuation in 0.7%; most common were headache [11%], fatigue [9%], nasopharyngitis [6%], nausea [5%], diarrhea [9%] and ALT elevations [5%], which were above 5 times ULN in 1.5%; adverse event rates were similar in cirrhotic and non-cirrhotic subjects).
Sulkowski MS, Moon JS, Sherman KE, Morelli G, Darling JM, Muir AJ, Khalili M, et al., PRIORITIZE Study Team. (2021). A pragmatic, randomized controlled trial of oral antivirals for the treatment of chronic hepatitis C: The PRIORITIZE Study. Hepatology. (Among 1128 adults with chronic hepatitis C, genotype 1, treated with either elbasvir and grazoprevir or sofosbuvir and ledipasvir for 12 weeks with or without ribavirin, SVR rates were similar [95% vs 97%], and 58% of subjects developed adverse events [severe in 1.8%], including liver related events in 7 patients [0.6%], one of which was severe: reactivation of hepatitis while on elbasvir and grazoprevir).
Torgersen J, Newcomb CW, Carbonari DM, Rentsch CT, Park LS, Mezochow A, Mehta RL, et al. (2021). Protease inhibitor-based direct-acting antivirals are associated with increased risk of aminotransferase elevations but not hepatic dysfunction or decompensation. J Hepatol. (Among propensity matched subgroups of 71,391 adults with chronic hepatitis C treated in the Veterans Administration Medical system with oral, direct acting antiviral agents, patients with higher baseline fibrosis scores compared to those with lower scores were more likely to have serum ALT elevations [>200 U/L] [0.5% vs 0.3%] and hepatic decompensation [0.41% vs 0.03%], and ALT elevations were more frequent with Viekira Pak and Technive [1.1-1.2%] compared to Mavyret, Zepatier, Epclusa, and Harvoni [0.11-0.39%]).

## OTHER REFERENCE LINKS

1 Recent References on Zepatier, Elbasvir, Grazoprevir: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(zepatier%3Cbr%3EGrazoprevir,%20Elbasvir/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Zepatier, Elbasvir, Grazoprevir: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=zepatier%3Cbr%3EGrazoprevir,%20Elbasvir)